# Angiotensin-Converting Enzyme Inhibitors

## OVERVIEW

The angiotensin-converting enzyme (ACE) inhibitors are a widely used class of antihypertensive medications that act by blocking the conversion of angiotensin I to angiotensin II, thus inhibiting an intermediate step in the renin-angiotensin pathway. The ACE inhibitors are rare causes of clinically apparent liver injury.

The ACE inhibitors act by blocking the conversion of angiotensin I to angiotensin II, the active peptide that causes the vasoconstriction and sodium retention induced by activation of the renin-angiotensin pathway. The ACE inhibitors are considered first line drugs for the therapy of hypertension and are considered particularly helpful in preventing the renal complications of diabetes and high blood pressure. ACE inhibitors are sometimes used even in patients with relatively normal blood pressure for treatment of heart failure and prevention of diabetic neuropathy. Currently, there are 10 ACE inhibitors approved for use in the United States: captopril (Capoten: 1981), enalapril (Vasotec: 1985), lisinopril (Prinivil, Zestril: 1987), benazepril (Lotensin: 1991), fosinopril (Monopril: 1991), quinapril (Accupril: 1991), ramipril (Altase: 1991), perindopril (Aceon: 1993), moexipril (Univasc: 1995), and trandolapril (Mavik: 1996).

All of the currently used ACE inhibitors are associated with a low rate of serum enzyme elevations during chronic therapy (0.2% to 2%) which is minimally different from the rate of elevations during placebo therapy. The aminotransferase elevations are usually mild-to-moderate in severity, self limited, and rarely require dose modification or drug discontinuation.

As a class, the ACE inhibitors have also been associated with instances of acute liver injury that is usually cholestatic and self limited in course. Clinically apparent liver injury from ACE inhibitors is, however, rare. The onset is typically within 1 to 8 weeks of starting the medication. Immunoallergic features (fever, rash, eosinophilia) can occur, but are rarely prominent. Autoantibody formation is uncommon. The largest numbers of cases of clinically apparent liver injury have been reported with captopril and enalapril. At present, however, lisinopril seems to be the most common cause of clinically apparent liver injury due to ACE inhibitors. Published cases of lisinopril liver injury have been somewhat distinctive, typically presenting with a hepatocellular pattern of serum enzyme elevations and a potentially severe course, which can be fatal. This pattern is less common with the other ACE inhibitors. Strikingly, several of the ACE inhibitors have been associated with instances of acute liver injury arising after 1 to 4 years of therapy, a distinctly unusual pattern. In some situations, the acute liver injury follows a escalation in drug dose, but in other situations there seems to be little explanation for the sudden onset of hepatic injury after years of safe use.

Persons who develop clinically apparent liver injury from an ACE inhibitor usually (but not always) have a recurrence when switched to another ACE inhibitor. Thus, if this class of antihypertensive agents is felt to be necessary, careful monitoring after starting the new agent is warranted.

The different ACE inhibitors are discussed separately, although the clinically apparent liver injury associated with their use is somewhat similar. Some of the less commonly used ACE inhibitors have not been linked to cases of hepatotoxicity, but all should be at least suspected of causing clinically apparent liver injury. References on their safety and hepatotoxicity are given together after this introduction.

- Benazepril
- Captopril
- Enalapril
- Fosinopril
- Lisinopril
- Moexipril
- Perindopril
- Quinapril
- Ramipril
- Trandolapril

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Benazepril | 86541-75-5 | C24-H28-N2-O5 | Benazepril Chemical Structure
Captopril | 62571-86-2 | C9-H15-N-O3-S | Captopril Chemical Structure
Enalapril | 75847-73-3 | C20-H28-N2-O5 | Enalapril Chemical Structure
Fosinopril | 98048-97-6 | C30-H46-N-O7-P | Fosinopril Chemical Structure
Lisinopril | 83915-83-7 | C21-H31-N3-O5.2H2-O | Lisinopril Chemical Structure
Moexipril | 103775-10-6 | C27-H34-N2-O7 | Moexipril Chemical Structure
Perindopril | 82834-16-0 | C19-H32-N2-O5 | Perindopril Chemical Structure
Quinapril | 82586-55-8 | C25-H30-N2-O5.Cl-H | Quinapril Chemical Structure
Ramipril | 87333-19-5 | C23-H32-N2-O5 | Ramipril Chemical Structure
Trandolapril | 87679-37-6 | C24-H34-N2-O5 | Trandolapril Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 February 2018

Zimmerman HJ. Antihypertensive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 654-5. (Expert review of hepatotoxicity published in 1999; discusses captopril which was implicated in at least 20 instances of liver injury with variable manifestations; enalapril in at least 7 cases; and lisinopril in several cases, some of which were fatal).
De Marzio DH, Navarro VJ. Angiotensin-converting enzyme inhibitors. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 523. (Review of hepatotoxicity of cardiovascular agents mentions that transient ALT elevations occur at a low rate during therapy with ACE inhibitors and that hepatotoxicity has been reported with benazepril, captopril, enalapril, fosinopril and lisinopril but not moexipril, perindopril, quinapril and trandolapril, perhaps because they are infrequently used).
Hilal-Dandan R. Renin and angiotensin. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 721-44. (Textbook of pharmacology and therapeutics mentions that hepatotoxicity is an extremely rare but reversible side effect).
Michel T, Hoffman BB. Angiotensin converting enzyme inhibitors. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics).
Atkinson AB, Robertson JI. Captopril in the treatment of clinical hypertension and cardiac failure. Lancet 1979; 2: 836-9. (Review of captopril as therapy of hypertension and heart failure; most common "unwanted effects" include rash and fever, loss of taste, proteinuria, renal dysfunction and postural hypotension; no mention of ALT elevations or hepatotoxicity). 90928
Vandenburg M, Parfrey P, Wright P, Lazda E. Hepatitis associated with captopril treatment. Br J Clin Pharmacol 1981; 11: 105-6. (Initial report of captopril hepatotoxicity: 64 year old man developed jaundice 6 months after starting captopril [bilirubin 8.4 mg/dL, AST 780 U/L, Alk P 338 U/L], resolving upon stopping). 7011347
Vidt DG, Bravo EL, Fouad FM. Medical intelligence drug therapy: captopril. N Engl J Med 1982; 306: 214-9. (Review of captopril, the first orally available ACE inhibitor; adverse events discussed include hematologic, renal and cutaneous, but not hepatic reactions). 7033784
Ram CV. Captopril. Arch Intern Med 1982; 142: 914-6. (Review of the history of development of ACE inhibitors as well as clinical effects and side effects of captopril; no mention of ALT elevations or hepatotoxicity). 6282230
Hurault de Ligny B, Mariot A, Kessler M, Caraman PL, Netter P. [Hepatitis during captopril combination therapy] Therapie 1982; 37: 698-700. French. (71 year old developed urticaria 10 days after starting captopril [bilirubin normal, ALT 183 U/L, Alk P 1972 U/L], rapidly resolving on stopping). 6762682
Ryckelynck JP, Batho JM, Peny J, Beuve-Mery P. [Hepatitis due to captopril] Nouv Presse Med 1982; 11: 1950-1. French. (36 year old woman developed liver test abnormalities [bilirubin 0.4 mg/dL, ALT 550 U/L, GGT 14 U/L] 20 months after starting captopril which improved on stopping and recurred on restarting). 7050898
Zimran A, Abraham AS, Hershko C. Reversible cholestatic jaundice and hyperamylasaemia associated with captopril treatment. Br Med J (Clin Res Ed) 1983; 287: 1676. (74 year old woman developed jaundice and itching 7 weeks after starting captopril [bilirubin 7.5 mg/dL, ALT 208 U/L, Alk P 1260 U/L], resolving within 2 weeks of stopping). 6196077
Navis GJ, de Jong PE, Kallenberg CG, de Monchy J, de Zeeuw D. Absence of cross-reactivity between captopril and enalapril. Lancet 1984; 1: 1017. (50 year old man developed rash and eosinophilia 3 months after starting captopril with positive skin tests; later tolerated enalapril without problems). 6143933
Parker WA. Captopril-induced cholestatic jaundice. Drug Intell Clin Pharm 1984; 18: 234-5. (54 year old woman developed jaundice and itching 4 weeks after starting captopril [bilirubin 22.2 mg/dL, ALT 43 U/L, Alk P 515 U/L], slowly resolving on stopping, normal 3 months later). 6365496
Rahmat J, Gelfand RL, Gelfand MC, Winchester JF, Schreiner GE, Zimmerman HJ. Captopril-associated cholestatic jaundice. Ann Intern Med 1985; 102: 56-8. (Case report and clinical review: 40 year old woman developed fever followed by jaundice and pruritus 2 weeks after starting captopril [peak bilirubin 26.6 mg/dL, AST 181 U/L, Alk P 11 times ULN, 18% eosinophils], resolving slowly upon stopping; among 14 cases spontaneously reported to the FDA, 9 were cholestatic, the typical latency was 1-8 weeks, eosinophilia and fever occurred in many). 3881069
Taillan B, Pedinielli FJ, Blanc AP, Jauffret P, Ferrer JC. [Toxic hepatitis caused by captopril] Therapie 1985; 40: 263. French. (53 year old man developed elevations in Alk P [350 U/L] with minimal ALT [29 U/L] increases [bilirubin not mentioned], 2 weeks after starting captopril; levels falling to near normal within two weeks of stopping). 3895557
DiBianco R. Adverse reactions with angiotensin converting enzyme (ACE) inhibitors. Med Toxicol 1986; 1: 122-41. (Extensive review of side effects of captopril and enalapril; rare cases of hepatotoxicity have been reported, largely cholestatic). 3023783
Lunel F, Grippon P, Cadranel JF, Victor N, Opolon P. [Acute hepatitis after taking enalapril maleate (Renitec)] Gastroenterol Clin Biol 1987; 11: 174-5. French. (74 year old man developed abdominal discomfort 2 months after starting captopril and was later found to have abnormal liver tests [bilirubin 0.6 mg/dL, ALT 193 U/L, Alk P 180 U/L], resolving rapidly upon stopping and recurring on restarting). 3032724
Mikloweit P, Bienmüller H. [Drug-induced intrahepatic cholestasis caused by flecainide acetate and enalapril] Internist (Berl) 1987; 28: 193-5. German. (64 year old man was found to have abnormal liver tests [bilirubin normal, ALT 115 U/L, Alk P 454 U/L] 4 months after starting enalapril, improving upon stopping). 3034817
Tabibian N, Alpert L, Alpert E. Captopril-induced liver dysfunction. South Med J 1987; 80: 1173-5. (54 year old man developed nausea and abdominal pain 4 weeks after starting captopril and found to have jaundice 2 months later [bilirubin 25.0 mg/dL, ALT 73 U/L, Alk P 1054], with rapid improvement on stopping). 3306948
Shionoiri H, Nomura S, Oda H, Kimura K, Takasaki I, Takagi N, Gotoh E. Hepatitis associated with captopril and enalapril but not with delapril in a patient with congestive heart failure receiving chronic hemodialysis. Curr Ther Res 1987; 42: 1171-6. Not in PubMed. (43 year old man with chronic renal failure on hemodialysis developed abnormal liver tests 5 days after starting captopril [bilirubin 0.6 mg/dL, ALT rising from 44 to 141 U/L, Alk P 208 to 389 U/L], improving on stopping but rising again 10 days after starting enalapril [bilirubin 0.8 mg/dL, ALT 148 U/L, Alk P 915 U/L], but not after switching to delapril).
Todd PA, Heel RC. Enalapril. A review of its pharmacodynamic and pharmacokinetic properties, and therapeutic use in hypertension and congestive heart failure. Drugs 1986; 31: 198-248. (Extensive review of enalapril, a prodrug that is hydrolyzed after absorption to the active form, enalaprilat which is poorly absorbed but is not further metabolized by the liver and is excreted in the urine; adverse events assessed in ~5000 patients, serious events were rare and no deaths were attributed to therapy; common side effects were cough, headache, dizziness and nausea; rare side effects granulocytopenia, rash and nephrotic syndrome; no mention of hepatotoxicity or ALT levels). 3011386
Gomez HJ, Cirillo VJ, Moncloa F. The clinical pharmacology of lisinopril. J Cardiovasc Pharmacol 1987; 9 Suppl 3: S27-34. (Lisinopril undergoes minimal hepatic metabolism and has few significant drug interactions). 442549
Rush JE, Merrill DD. The safety and tolerability of lisinopril in clinical trials. J Cardiovasc Pharmacol 1987; 9 Suppl 3: S99-107. (Among 1476 patients receiving lisinopril in clinical trials, side effects were mild; headache [6%], dizziness [6%], cough [4%] and diarrhea [3%] being more common than with placebo, no deaths, serious adverse events, or drug discontinuations for liver related adverse events; ALT elevations not mentioned). 2442561
Edwards IR, Coulter DM, Beasley DM, MacIntosh D. Captopril: 4 years of post marketing surveillance of all patients in New Zealand. Br J Clin Pharmacol 1987; 23: 529-36. (Postmarketing surveillance of captopril from Australia; among 4124 patients treated, 220 adverse event reports, but no mention of ALT elevations or hepatotoxicity). 3297125
Warner NJ, Rush JE. Safety profiles of the angiotensin-converting enzyme inhibitors. Drugs 1988; 35 Suppl 5: 89-97. (Side effects from ACE inhibitors appear to be a class effect, with headache, dizziness, fatigue, nausea, change in taste, rash and cough most common: liver injury and ALT elevations not discussed). 3063490
Zannad F, Marie PY, Aliot E, Trechot P, Gilgenkrantz JM. Cytolytic hepatitis with captopril but not with enalapril. Cardiovasc Drugs Ther 1988; 1: 669-70. (54 year old woman developed fever and fatigue 22 days after starting captopril [bilirubin normal, ALT 348 U/L, Alk P 450 U/L, eosinophils 660/μL], resolved 2 weeks after stopping; later tolerated enalapril without incident). 2856462
Bellary SV, Isaacs PE, Scott AW. Captopril and the liver. Lancet 1989; 2: 514. (Two women and one man with liver injury during captopril therapy, ages 69-88 years, onset after 2, 6 and 12 weeks, 2 were jaundiced and 1 died [bilirubin 0.6-6.1 mg/dL, AST 76-169 U/L, Alk P 394-505 U/L]). 2570229
Martin T, Taupignon A, Graf E, Perrin D. [Pancreatitis and hepatitis in a patient treated with enalapril maleate. A case report] Therapie 1989; 44: 449-50. French. (33 year old woman developed jaundice 3-4 weeks after starting enalapril [peak bilirubin 9.3 mg/dL, ALT 10 times ULN, Alk P 2 times ULN], resolving upon stopping). 2560267
Rosellini SR, Costa PL, Gaudio M, Saragoni A, Miglio F. Hepatic injury related to enalapril. Gastroenterology 1989; 97: 810. (54 year old woman found to have abnormal ALT [1145 U/L] and Alk P [144 U/L], but normal bilirubin 7 weeks after starting enalapril with rapid improvement on stopping). 2546851
Lorenzo A, Colomés L, Igual J. [Transaminase elevation and captopril] Aten Primaria 1989; 6: 364. Spanish. (68 year old woman found to have ALT elevations [68-79 U/L] with symptoms 3 months after starting captopril, resolving within 2 weeks of stopping). 2491596
Lobos JM, del Valle J. [Captopril and transaminase increase. A causal or incidental relation?] Aten Primaria 1990; 7: 400, 402. Spanish. (Letter in response to Lorenzo [1989] arguing that ALT elevations on captopril were incidental). 2129707
Knapp LE, Frank GJ, McLain R, Rieger MM, Posvar E, Singer R. The safety and tolerability of quinapril. J Cardiovasc Pharmacol 1990; 15 Suppl 2: S47-55. (Overview of safety of quinapril based upon results in 2697 patients in 56 clinical trials found low rates of side effects that were similar to those of other ACE inhibitors: "quinapril, enalapril, and captopril had only minor effects on parameters used to assess hepatic function and the changes were comparable with those in patients treated with placebo"). 1691407
Larrey D, Babany G, Bernuau J, Andrieux J, DeGott C, Pessayre D, Benhamou J-P. Fulminant hepatitis after lisinopril administration. Gastroenterology 1990; 99: 1832-3. (55 year old man developed jaundice 2 weeks after starting lisinopril that continued to worsen for 5 weeks after stopping [bilirubin 18.4 rising to 70 mg/dL, ALT 2510 U/L, protime 90% falling to 42%], patient dying after emergency surgery for perforated duodenal ulcer). 2172073
Todd P, Levison D, Farthing MJ. Enalapril-related cholestatic jaundice. J R Soc Med 1990; 83: 271-2. (67 year old woman developed jaundice and pruritus 6 weeks after starting enalapril [bilirubin 8.9 mg/dL, AST 236 U/L, Alk P 437 U/L], resolving within 4 months of stopping). 2342045
Crantock L, Prentice R, Powell L. Cholestatic jaundice associated with captopril therapy. J Gastroenterol Hepatol 1991; 6: 528-30. (81 year old woman developed jaundice and pruritus 2 weeks after starting captopril [bilirubin 20.3 mg/dL, ALT 57 U/L, Alk P 368 U/L]; patient died of cardiac arrest during recovery). 1932674
Hagley MT. Captopril-induced cholestatic jaundice. South Med J 1991; 84: 100. (66 year old woman developed jaundice and pruritus 3 weeks after starting captopril [bilirubin 15.1 mg/dL, ALT 202 U/L, Alk P 587 U/L], resolving within 4 weeks of stopping). 1986415
Kitai E, Sandiuk A, Zalewski S. Enalapril-induced immunologic impairment of hepatic function. J Fam Pract 1991; 33: 301-2. (59 year old woman found to have high Alk P [305 U/L], but normal AST and bilirubin, 8 weeks after starting enalapril, resolving within 2 months of stopping). 1880490
Putterman C, Livshitz T. [Captopril-induced liver dysfunction] Harefuah 1991; 121: 92-3. Hebrew. (71 year old man with heart failure after a myocardial infarction, developed enzyme elevations 2 days after captopril was started [peak bilirubin 1.3 mg/dL, ALT 135 U/L, Alk P 450 U/L, GGT 780 U/L], resolving within 4 weeks of stopping). 1752582
Alonso-Villaverde C, Ubiría J, Masana L, Prats E.[Cholestasis caused by captopril] Med Clin(Barc) 1992; 99: 595. Spanish. (52 year old woman developed jaundice and itching 2 weeks after starting captopril [bilirubin 10.3 rising to 20.0 mg/dL, ALT 102 U/L, Alk P 240 U/L], resolving slowly, symptoms within 2 months but enzyme elevations lasting 10 months). 1460917
Hagley MT, Benak RL, Hulisz DT. Suspected cross-reactivity of enalapril- and captopril-induced hepatotoxicity. Ann Pharmacother 1992; 26: 780-1. (51 year old man developed jaundice within 1 month of starting enalapril [peak bilirubin 0.6 mg/dL, ALT 89 U/L, Alk P 798 U/L], resolving with stopping, but recurring after taking captopril for a year [peak bilirubin 21.9 mg/dL, ALT 203 U/L, Alk P 687 U/L], resolving slowly and incompletely on stopping). 1611160
Materson BJ. Adverse effects of angiotensin-converting enzyme inhibitors in antihypertensive therapy with focus on quinapril. Am J Cardiol 1992; 69: 46C-53C. (Among 1771 patients treated with quinapril in clinical trials, side effects were comparable to other ACE inhibitors, including cough, dizziness and somnolence: no mention of ALT elevations or hepatotoxicity). 1546639
Parish RC, Miller LJ. Adverse effects of angiotensin converting enzyme(ACE) inhibitors. An update. Drug Saf 1992; 7: 14-31. (General review of side effects of ACE inhibitors, mentions a single case of hepatotoxicity [Tabibain 1987]). 1536695
Pedersen JH, Clementsen PS, Høyer S, Hansen BA. [Captopril-induced toxic hepatitis] Ugeskr Laeger 1992; 154: 2911-2. Danish. (74 year old woman developed fever and abdominal pain 4 weeks after starting captopril [bilirubin 28 mg/dL, ALT 477 U/L, Alk P 1444 U/L] with progressive hepatic failure and death 5 weeks later). 1413240
de Vega T, Rúa-Figueroa I, Soto J, Sacristán JA. [Cholestatic jaundice induced by captopril] Med Clin(Barc) 1992; 98: 518. Spanish. (86 year old woman developed abdominal pain and jaundice 3 months after starting captopril [bilirubin 3.0 mg/dL, ALT 66 U/L, Alk P 798 U/L], rapid recovery on stopping). 1583956
Hagley MT, Hulisz DT, Burns CM. Hepatotoxicity associated with angiotensin-converting enzyme inhibitors. Ann Pharmacother 1993; 27: 228-31. (Review of 19 cases of ACE inhibitor associated liver injury: usually cholestatic [68%], none hepatocellular; 2 cases of cross reactivity with other ACE inhibitors; latency variable, median being 4 weeks). 8292107
Hilburn RB, Bookstaver D, Whitlock WL. Comment: angiotensin-converting enzyme inhibitor hepatotoxicity: further insights. Ann Pharmacother 1993; 27: 1142-3. (In response to article by Hagley [1993], mentions a case of hepatotoxicity due to lisinopril, but no details are provided). 8219456
Lindgren A, Olsson R. [Liver damage following antihypertensive therapy. A case report of hepatitis induced by lisinopril and a review] Lakartidningen 1993; 90: 1557-8. Swedish. (72 year old man developed jaundice 12 months after starting lisinopril [peak bilirubin 14.9 mg/dL, ALT 2040 U/L, Alk P 360 U/L], resolving within 2 months of stopping). 8387127
Valle R, Carrascosa M, Cillero L, Perez-Castrillon JL. Enalapril-induced hepatotoxicity. Ann Pharmacother 1993; 27: 1405. (73 year old woman developed fatigue within 10 days of switching from lisinopril to enalapril [bilirubin 0.9 mg/dL, ALT 614 U/L, Alk P 470 U/L], resolving within 10 days of stopping). 8286822
Hürlimann R, Binek J, Oehlschlegel C, Hammer B. [Enalapril (Reniten)-associated toxic hepatitis] Schweiz Med Wochenschr 1994; 124: 1276-80. German. (52 year old woman developed fatigue after 12 and jaundice after 20 weeks of enalapril therapy [bilirubin 29.5 mg/dL, ALT 1585 U/L, Alk P 309 U/L, protime 46%], resolving 5 months after stopping). 8066414
Droste HT, de Vries RA. Chronic hepatitis caused by lisinopril. Neth J Med 1995; 46: 95-8. (56 year old man developed jaundice, 4 months after starting lisinopril [bilirubin 5.3 mg/dL, ALT 1768 U/L, Alk P 178 U/L], but drug continued for another month [bilirubin 33.5 mg/dL, ALT 2420 U/L, Alk P 113 U/L], slow recovery upon stopping and liver biopsy 9 months later showed incomplete cirrhosis). 7885528
Harrison BD, Laidlaw ST, Reilly JT. Fatal aplastic anaemia associated with lisinopril. Lancet 1995; 3469: 247-8. (64 year old woman developed aplastic anemia 17 days after starting enalapril [bilirubin 4.4 mg/dL, ALT 548 U/L, Alk P normal, white count 350/μL, platelets 12,000/μL], dying shortly after of sepsis). 7616816
Nissan A, Spira RM, Seror D, Ackerman Z. Captopril-associated "pseudocholangitis'. A case report and review of the literature. Arch Surg 1996; 131: 670-1. (65 year old woman developed abdominal pain, fever and jaundice 2 months after starting captopril and delayed stopping [bilirubin rising from 3.3 to 21 mg/dL, ALT 515 U/L, Alk P 157 U/L], taking 5 months to recover). 8645078
Deira JL, Corbacho L, Bondía A, Lerma JL, Gascón A, Martín B, García P, Tabernero JM. Captopril hepatotoxicity in a case of renal crisis due to systemic sclerosis. Nephrol Dial Transplant. 1997; 12: 1717-8. (70 year old woman with renal failure due to scleroderma developed jaundice 21 days after starting captopril [bilirubin 14.3 mg/dL, ALT 330 U/L, Alk P 345 U/L] and rapid improvement on stopping). 9269658
Edwards C, Blowers DA, Pover GM. Fosinopril national survey: a post-marketing surveillance study of fosinopril (Staril) in general practice in the UK. Int J Clin Pract 1997; 51: 394-8. (Postmarketing study of 10,791 hypertensive patients from the UK treated with fosinopril for an average of 5.2 months, side effects were reported in 24% including cough [6%], dizziness [2.5%], headache [2%], fatigue [1%], nausea [1%]; 10% stopped because of side effects, but no mention of liver injury or ALT elevations). 9489071
Berdah J, Guest M, Salvador M. [Study of the efficacy and safety of fosinopril in general practice in 19,435 hypertensive patients (FLIGHT Study)]. Ann Cardiol Angeiol (Paris) 1998; 47: 169-75. French. (Postmarketing study of 19,435 hypertensive patients from France treated with fosinopril for at least 12 weeks; side effects reported in 12% including cough in 2.7%; no mention of ALT elevations or liver related adverse events). 9772944
Peters DC, Noble S, Plosker GL. Trandolapril. An update of its pharmacology and therapeutic use in cardiovascular disorders. Drugs 1998; 56: 871-93. (Review of trandolapril, an ACE inhibitor with once daily dosing, minimally metabolized by liver; among >24,000 patients in clinical trials, common side effects were cough [3.6%], fatigue [1%], dizziness [0.9%], headache [0.7%] and nausea [0.6%]; no mention of ALT elevations or hepatotoxicity). 9829159
Martínez Gutiérrez A, Sierra Manzano JM, Tapia YR, Larumbe Sola Y. [Hepatotoxicity caused by captopril] Aten Primaria 1998; 21: 586-7. Spanish. (60 year old man developed jaundice and pruritus 4 weeks after starting captopril [bilirubin 13.1 mg/dL, ALT 1180 U/L, Alk P 1468 U/L], resolving 8-10 weeks after stopping). 9670588
Pérez Roldán F, González Carro PS, Legaz Huidobro ML, Saez Bravo JM, Ruiz Carrillo F. [Cholestatic hepatitis caused by captopril] Rev Esp Enferm Dig 1998; 90: 378-9. Spanish. (71 year old man developed abdominal pain, fever and jaundice 3 months after starting captopril [bilirubin 11.4 mg/dL, ALT 210 U/L, Alk P 451 U/L], resolving 6 months after stopping). 9656763
Quílez C, Palazón JM, Chuliá T, Córdoba YC. [Hepatoxicity by enalapril] Gastroenterol Hepatol 1999; 22: 113-4. Spanish. (45 year old man developed abdominal pain and jaundice 2 years after starting enalapril [bilirubin 18 mg/dL, ALT 5300 U/L, Alk P 381 U/L], recovering in 2 months). 10193097
Hourmand-Ollivier I, Dargere S, Cohen D, Galais MP, Mosquet B, Rousselot P, Dao T. [Fatal subfulminant hepatitis probably due to the combination benazepril-hydrochlorothiazide(Briazide)]. Gastroenterol Clin Biol 2000; 24: 464. French. (69 year old woman developed fatigue 14 months after starting benazepril with HCTZ [bilirubin 16.2 mg/dL, ALT 30 times ULN, Alk P 2 times ULN, protime 63%], with progressive course and death; delayed discontinuation). 10844292
Jeserich M, Ihling C, Allgaier HP, Berg PA, Heilmann C. Acute liver failure due to enalapril. Herz 2000; 25: 689-93. (46 year old man developed fatigue and jaundice 3 years after starting enalapril [bilirubin 13.8 rising to 46.7 U/L, ALT 936 U/L, Alk P 394 U/L], progressing for 6 weeks despite stopping and requiring liver transplantation; died of complications). 11141678
Kocab MA, Coppola D, Hiotis S, Karl RC, Barthel JS. Captopril-associated cholestasis complicating the management of pancreatic cancer. Surg Endosc 2000; 14: 681. (Abstract only; no details of case). 11265073
Clark LT. Safety profile of perindopril. Am J Cardiol 2001; 88: 36i-40i. ( Review of safety data from more than 2,500 patients treated with perindopril for up to 4 years and from postmarketing reports stated that the most common [>1%] side effects were cough, gastrointestinal upset, fatigue, headache and dizziness; no mention of clinically apparent liver injury or ALT elevaitons). 11591359
González de la Puente MA, Calderón E, Espinosa R, Rincón M, Varela JM. Fatal hepatotoxicity associated with enalapril. Ann Pharmacother 2001; 35: 1492. (80 year old woman developed jaundice 3 weeks after starting enalapril [bilirubin 17 rising to 46 mg/dL, ALT 244 U/L, Alk P 1999 U/L], progressing to hepatic failure and death by day 30). 11724106
Nunes AC, Amaro P, Maç as F, Cipriano A, Martins I, Rosa A, Pimenta I, et al. Fosinopril-induced prolonged cholestatic jaundice and pruritus: first case report. Eur J Gastroenterol Hepatol 2001; 13: 279-82. (61 year old man developed jaundice 2-4 weeks after starting fosinopril [bilirubin 19.1 rising to 40 mg/dL, ALT 70 U/L, Alk P 421 U/L] with prolonged pruritus [4 months] and Alk P elevations [18 months]). 11293449
Romero-Gómez M, Miralles EJ, García Díaz E, Robles A, Suárez E, Castro M. Hepatotoxicity induced by fosinopril. J Hepatol 2001; 35: 309-10. (43 year old man developed jaundice and pruritus 3 months after starting fosinopril [bilirubin 7.9 mg/dL, ALT 331 U/L, Alk P 1430 U/L], resolving within 4 weeks of stopping). 11580159
Schattner A, Kozak N, Friedman J. Captopril-induced jaundice: report of 2 cases and a review of 13 additional reports in the literature. Am J Med Sci 2001; 322: 236-40. (1 woman and 1 man developed cholestatic hepatitis due to captopril: 67 and 73 year olds treated for 2 and 26 months [bilirubin 9.9 and 14.0 rising to 30 and 24.4 mg/dL, ALT 268 and 305 U/L, Alk P 363 and 917 U/L], both resolving within ~4 months of stopping). 11678523
Hartleb M, Biernat L, Kochel A. Drug-induced liver damage -- a three-year study of patients from one gastroenterological department. Med Sci Monit 2002; 8: CR292-6. (Among 14 cases of drug induced liver injury seen over a 3 year period, none were fatal; 3 cases due to amoxicillin/clavulanate, 3 statins, 2 antituberculosis medications, and 1 each for roxithromycin, asacol, methimazole, estrogens, satolol and enalapril [66 year old woman with onset after 4 weeks and bilirubin 17 mg/dL, ALT 1.2 times and Alk P 2.2 times ULN]). 11951073
Muela Molinero A, Linares Torres P, Domínguez Carbajo AB, Olcoz Goñi JL. [Enalapril induced cholestasic hepatitis] An Med Interna 2002; 19: 492-3. Spanish. (73 year old man developed jaundice within 3 months after starting enalapril [bilirubin 10.8 mg/dL, ALT 87 U/L, Alk P 853 U/L], resolving upon stopping). 1242064
Schoondyke JW, Mohan R, Kelly JL, Ponder MA, Iskandar S, Douglas JE. Fosinopril-induced hepatotoxicity in a complex medical patient. Tenn Med 2002; 95: 155-6. (74 year old woman developed jaundice within 3 days of starting fosinopril while on artificial ventilation, improving upon stopping drug; no details or laboratory test results given). 11941910
Bas V, Erkan T, Caliskan S, Sever L, Kasapçopur O, Ozbay G, ArIsoy N. Toxic hepatitis due to enalapril in childhood. Pediatr Int 2003; 45: 755-7. (7 year old girl developed liver injury after 4 years of enalapril therapy for nephritic syndrome [bilirubin 1.9 mg/dL, ALT 1318 U/L, Alk P 727 U/L], resolving completely in one month with prednisone therapy). 14651558
Macías FM, Campos FR, Salguero TP, Soria PT, Carrasco FG, Martín JM. Ductopenic hepatitis related to Enalapril. J Hepatol 2003; 39: 1091-2. (58 year old man on enalapril for 2 years developed jaundice and abdominal pain [bilirubin 10 mg/dL, ALT 133 U/L, Alk P 382 U/L], 2 biopsies showed ductopenia and cholestasis; slow but eventual complete recovery). 14642633
Yeung E, Wong FS, Wanless IR, Shiota K, Guindi M, Joshi S, Gardiner G. Ramipril-associated hepatotoxicity. Arch Pathol Lab Med 2003; 127: 1493-7. (Three men with suspected ramipril hepatotoxicity; ages 51, 59 and 51 years with onset after 4, 2 and 8 weeks [peak bilirubin 15.5, 5.0, and 1.4 mg/dL, ALT 103, 28, and 134 U/L, Alk P 957, 352 and not available U/L], slow resolution in cholestatic cases, rapid in case with enzyme elevation only; one possibly had vanishing bile duct syndrome and cirrhosis and had persistence of jaundice for more than a year). 14567716
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, causes include one case attributed to lisinopril, but none to other ACE inhibitors). 15390328
Chrysant SG, Chrysant GS. Pharmacological and clinical profile of moexipril: a concise review. J Clin Pharmacol 2004; 44: 827-36. (Moexipril is a prodrug of the carboxylic metabolite moexiprilat; its pharmacokinetics allow once daily dosing, and it has similar activity and side effects to other ACE inhibitors: commonly cough, vertigo, diarrhea and fatigue: no mention of ALT elevations or hepatotoxicity). 15286086
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of DILI with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002; 103 cases identified as highly probable, probable or possible including one attributed to enalapril and one to captopril). 16165719
Andrade RJ, Lucena MI, Kaplowitz N, García-Munoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (Among cases of drug induced liver injury in the Spanish registry, ACE inhibitors accounted for 5 of 406 cases of acute [~1%] and 2 of 28 cases [7%] of chronic injury, largely with cholestatic injury). 17133470
Maimon N, Ferguson ND, Marras TK. Angiotensin converting enzyme inhibitor toxicity causing interstitial pneumonitis and cholestatic hepatitis. Eur J Intern Med 2006; 17: 73. (62 year old woman developed fever, cough and liver test abnormalities while taking atorvastatin and enalapril for an unstated period [no liver test values provided], resolving after stopping; few details given). 16378897
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain; calculated relative risk [RR] of injury compared to the general population: for 8 cases due to antituberculosis triple therapy [RR=1300], but for 9 cases of captopril RR=3 [nonsignificant] and 6 cases of enalapril RR=1.5 [nonsignificant]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 cases were attributed to ACE inhibitors, one to lisinopril [judged as probable] and one quinapril [judged as only possible]). 18955056
Chou JW, Yu CJ, Chuang PH, Lai HC, Hsu CH, Cheng KS, Peng CY, et al. Successful treatment of fosinopril-induced severe cholestatic jaundice with plasma exchange. Ann Pharmacother 2008; 42: 1887-92. (78 year old man developed jaundice 1 month after starting fosinopril [bilirubin 21.4 mg/dL, ALT 41 U/L, Alk P 242 U/L], resolving within 2 months of stopping). 19017832
Palta R, Thobani S, Donovan JA, Kanel GC, Gutierrez G, Fong TL. Prolonged cholestasis associated with benazepril therapy. Am J Gastroenterol 2009; 104: 245-6. (Case report of a 32 year old woman who developed painless jaundice and pruritus 14 weeks after starting benazepril; causality was graded as probable on the Naranjo scale; liver tests peaked 14 days after stopping benazepril [total bilirubin 22.0 mg/dL, ALT 143 U/L, Alk P 3904 U/L], liver tests normalized 10 months after onset). 19098880
Zalawadiya SK, Sethi S, Loe S, Kumar S, Tchokonte R, Shi D, Adam AK, May EJ. Unique case of presumed lisinopril-induced hepatotoxicity. Am J Health Syst Pharm 2010; 67: 1354-6. (30 year old woman developed jaundice 8 months after starting lisinopril [bilirubin 12.2 mg/dL, ALT 1638 U/L, Alk P 175 U/L], with resolution within 2 months of stopping). 20689125
da Silva GH, Alves AV, Duques P, Sevá-Pereira T, Soares EC, Escanhoela CA. Acute hepatotoxicity caused by enalapril: a case report. J Gastrointestin Liver Dis 2010; 19: 187-90. (44 year old man developed jaundice 2.5 years after starting enalapril and 3 months after a dose increase [bilirubin 16.4 mg/dL, ALT 370 U/L, Alk P 668 U/L], with improvement on stopping, relapse on restarting, and eventual slow recovery). 20593053
Bruggisser M, Terraciano L, Rätz Bravo A, Haschke M. [Liver damage in a patient treated with a vitamin K antagonist, a statin and an ACE inhibitor]. Praxis (Bern 1994) 2010; 99: 1259-65. German. (71 year old man developed jaundice while receiving phenprocoumon, atorvastatin and perindopril [bilirubin 6.3 mg/dL, ALT 1526 U/L, Alk P 187 U/L], with rapid improvement on stopping; phenprocoumon thought to be the cause). 20960395
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to ACE inhibitors). 20949552
Douros A, Kauffmann W, Bronder E, Klimpel A, Garbe E, Kreutz R. Ramipril-induced liver injury: case report and review of the literature. Am J Hypertens 2013; 26: 1070-5. (40 year old man with recurrent alcoholic pancreatitis developed jaundice 10 months after starting ramipril [bilirubin 1.9 mg/dL, ALT 888 U/L, Alk P 599 U/L], with rapid improvement on stopping and recurrence upon restarting ramipril [bilirubin 1.4 mg/dL, ALT 1555 U/L, Alk P 523 U/L]; review of literature on hepatotoxicity of ACE inhibitors). 23747952
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an ACE inhibitor despite their frequent use). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, antihypertensive agents accounted for 39 cases [4%] of which 8 [1%] were ACE inhibitors with 6 cases attributed to lisinopril, 1 to enalapril and 1 to benazepril). 25754159
Saloojee A, Skinner DL, Loots E, Hardcastle TC, Muckart DJ. Hepatic dysfunction: A common occurrence in severely injured patients. Injury 2017; 48: 127-32. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27599394) (Among 225 patients with severe traumatic injuries admitted to a South African trauma unit over a one year period, liver test abnormalities arose in 48 [21%] with initial and peak values of ALT of 93 and 156 U/L, Alk P of 63 and 238 U/L and bilirubin of 0.7 and 3.5 mg/dL, the presence of liver injury being associated with more severe injury, shock and renal failure, but also with use of piperacillin/tazobactam and enalapril, probably because of their use in patients with more severe injury).